# Timolol

## OVERVIEW

### Introduction

Timolol is a nonselective beta-adrenergic receptor blocker that is widely used for the therapy of hypertension, angina pectoris and prevention of vascular headaches. Timolol has yet to be convincingly associated with clinically apparent liver injury and is often used in patients with liver disease and cirrhosis.

### Background

Timolol (tim' oh lol) is a nonselective beta-blocker, acting on both beta-1 and beta-2 adrenergic receptors. Beta-1 adrenergic blockade reduces the heart rate and myocardial contractility by slowing the AV conduction and suppressing automaticity. Beta-2 blockade also affects peripheral vascular resistance and can cause bronchospasm and hypoglycemia. Timolol is indicated for the management of hypertension, angina pectoris, cardiac arrhythmias and reduction in the risk of cardiovascular mortality after myocardial infarction. Timolol is also used for the prevention of migraine amd vascular headaches and for lessening the risk of recurrent variceal hemorrhage in patients with cirrhosis and portal hypertension. Timolol was approved for use in the United States in 1995 and is still in wide use. Timolol is available in tablets of 5, 10 and 20 mg in generic forms and formerly under the trade name Blocadren. In addition, timolol is available in an ophthalmic formulation for therapy of ocular hypertension and glaucoma. The typical initial oral dose of timolol in adults is 10 mg twice daily, with subsequent dose modification based upon clinical response and tolerance, the average total daily maintenance dose being 10 to 60 mg. Common side effects of timolol include bradycardia, hypotension, fatigue, dizziness, depression, memory loss, impotence, cold limbs and less commonly severe hypotension, heart failure and bronchospasm. As with all beta-blockers, sudden withdrawal can trigger rebound hypertension. Beta-blockers are contraindicated in patients with asthma, bradycardia and heart failure and should be used cautiously in the elderly and in patients with diabetes.

### Hepatotoxicity

Mild-to-moderate elevations in serum aminotransferase levels occur in less than 2% of patients on timolol and are usually transient and asymptomatic, resolving even with continuation of therapy. Despite its wide spread use, timolol has not been convincingly linked to instances of clinically apparent liver injury. Other beta-blockers have been implicated in rare instances of acute liver injury with a latency to onset ranging from 2 to 24 weeks, a hepatocellular pattern of serum enzyme elevations and a mild, self-limiting course without evidence of hypersensitivity or autoimmune reactions.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

Timolol undergoes extensive metabolism by the liver and is excreted in the urine as inactive metabolites. The reason why timolol rarely causes liver injury is unknown; other beta-blockers with similar chemical structures have been linked to cases of clinically apparent, idiosyncratic liver injury.

References to the safety and potential hepatotoxicity of timolol are provided in the overview on Beta-Adrenergic Receptor Antagonists, last updated in June 2019.

Drug Class: Beta-Adrenergic Receptor Antagonists

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Timolol – Generic, Blocadren®

DRUG CLASS

Beta-Adrenergic Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=timolol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Timolol | 91524-16-2 | C13-H24-N4-O3-S.1/2H2-O | Timolol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Timolol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Timolol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Timolol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Timolol)